# Writing A Case Report

## Reporting a Case to MedWatch

All cases of drug-induced liver injury should be reported to the Food and Drug Administration (FDA). Reports to the FDA are easy to prepare and represent responsible citizenship. The reporting is to "MedWatch" which can be done on line at www.fda.gov/Safety/MedWatch. MedWatch forms can also be filled out by hand and sent by Fax or mail to the FDA: forms are available at the website above or by telephone request: toll free at 1-800-332-1088. The website link above will take you directly to the FDA MedWatch site. Filling out the forms takes 10 to 15 minutes if you have the information at hand. To assist the LiverTox site visitor in collecting and organizing clinical information needed to report a case to MedWatch, a description of “Reporting Elements” is provided on this website. This section has an on-line form (Important Elements in Reporting of Drug-Induced Liver Injury) which can be printed out and used as a work sheet to facilitate the MedWatch submission or a publication. The form provides a check list of clinical elements that are important in establishing the diagnosis, excluding other causes of liver disease and defining the severity, course and outcome of the liver injury.

## A guide to reporting a case of drug-induced liver disease

For most medications, drug induced liver injury is uncommon, idiosyncratic and unpredictable. For these reasons, drug-induced liver injury usually is difficult to diagnose, a challenge to manage and treat, and almost impossible to prevent. Awareness or suspicion of drug-induced liver disease, however, is critically important because otherwise the diagnosis may be missed, and harm done by continuing the drug or supplement in the face of worsening liver injury. Thus, the most important and critical part of management of drug induced liver injury is early diagnosis and prompt discontinuation of the suspected agent. Another important element of management, that is commonly overlooked, is to REPORT the case. The case first must be reported to the patient or patient’s family. Instructions should be given that the medication should be avoided in the future. It is prudent to ask the patient or family members to rid the home of the medication suspected to have caused liver injury. The residual medication can be given to the physician or a pharmacist to destroy. If the medication is unusual, such as an herbal, traditional medication, or nutritional supplement, it may be best to have it tested for purity and composition.

## Important Elements to include in Reporting Cases of Drug-induced Liver Injury

Diagnosis of drug-induced liver disease relies upon knowing the time to onset and recovery, pattern of injury, exclusion of other causes of liver disease, and whether there was a recurrence of injury with re-exposure. These features are the basis for recommending that specific data elements are necessary when cases of drug-induced liver injury are reported to a Federal Agency (such as the Food and Drug Administration through MedWatch), to the pharmaceutical manufacturer, and in preparing a manuscript for publication of a case report or case series. The data elements should include all the information needed for making a diagnosis and to assess causality in suspected drug-induced liver injury. Without these pieces of information, it may simply be impossible to say whether or not drug-induced liver disease is the cause of the liver injury. In assessing and describing cases of drug-induced liver disease, these elements should be considered necessary:

- Name of the medication (generic name)
- Dose and regimen of its administration
- Date that the Medication was Started
- Date the Medication was Stopped (or Duration of Therapy)
- Date of first onset of symptoms of liver injury or blood test abnormalities (or time to onset)
- Sequence of events after onset including symptoms, complications, interventions and serial laboratory tests (including ALT or AST or both, alkaline phosphatase, direct and total bilirubin, albumin and prothrombin time)
- Evidence of clinical and biochemical recovery after discontinuation of the implicated drug
- IgM anti-HAV to exclude hepatitis A
- IgM anti-HBc or HBsAg or both, to exclude hepatitis B
- Anti-HCV or HCV RNA or both to exclude hepatitis C
- Antinuclear antibody and globulin level to exclude autoimmune hepatitis
- Ultrasound of the liver and biliary system to exclude fatty liver disease and biliary obstruction
- Risk factors for other forms of acute liver disease such as exposure to viral hepatitis, alcohol use, recent weight gain, and recent episode of acute heart failure, hypoxemia or severe hypotension
- Previous history of liver disease
- Other medications being taken in the 2 months before onset of injury

## Other helpful pieces of information, that are not always available or necessary include:

- Previous history of exposure to the medication
- Previous history of drug-induced liver disease and drug allergies
- Previous liver test results before (or early during the course of) the administration of the medication
- Specialized testing to exclude uncommon causes of acute liver injury such as IgM antibody to hepatitis E virus (IgM anti-HEV), tests for mononucleosis or cytomegalovirus infection.
- Liver biopsy histology
- Results of re-challenge or re-exposure to the medication

A checklist to use in reporting a case of drug-induced liver injury is available by checking here.

Full assessment of the likelihood of drug-induced liver disease may require further time and follow up, largely to demonstrate that the liver disease resolves or improves after withdrawal of the medication and another diagnosis does not become clear (such as autoimmune hepatitis marked by persistence of disease or a relapsing course despite stopping the drug, or acute hepatitis C marked by absence of detectable levels of anti-HCV at the onset). This is appropriate because proper management of patients with drug-induced liver disease calls for adequate follow up and documentation that the liver disease has resolved. Drug-induced liver disease is usually acute and almost always self-limited. While medications can cause severe acute injury and death from liver failure, they rarely cause liver disease that persists despite discontinuation of the medication. There are instances, however, when chronic liver disease appears to arise as a result of a finite course of a medication.